# Nodular Regenerative Hyperplasia

Description. Nodular regenerative hyperplasia (NRH) is a form of noncirrhotic portal hypertension that can be caused by chronic use of medications. NRH typically presents with the insidious or unexpected onset of signs or symptoms of portal hypertension (weakness, ascites, splenomegaly, esophageal varices) in a patient with little evidence of chronic liver disease. The diagnosis is made by liver biopsy, showing absence of significant fibrosis and presence of nodularity usually best defined by reticulin staining. On superficial review, the liver biopsy may appear normal.

Latency to Onset. The time to onset of NRH is typically long, usually 1 to 6 years, but occasionally within 6 months.

Symptoms. NRH usually presents with the insidious onset of fatigue, weight loss, abdominal distension or other signs of portal hypertension such as ascites or variceal hemorrhage.

Serum Enzyme Elevations. Serum enzymes are usually normal or minimally elevated, although acute elevations in serum enzymes accompanied by what appears to be sinusoidal obstructive syndrome may precede the development of NRH. Jaundice is rare. The early development of NRH is manifested by an unexplained decrease in platelet count.

Drugs. Typical agents that cause nodular regenerative hyperplasia include azathioprine, thioguanine, mercaptopurine, didanosine, stavudine, isoplatin, vitamin A and possibly methotrexate.

Etiology. The pathogenesis and cause of nodular regenerative hyperplasia is not well defined. NRH occurs most commonly in patients with multiple, recurrent vascular and infectious complications such as in cystic fibrosis, common variable hypogammaglobulinemia, chronic granulomatous disease, and after solid organ transplantation. Drugs may contribute to these causes of NRH as well. The injury is likely vascular and may represent a small vessel vasculitis that injures the small portal veins. NRH is thus a regenerative response to vascular injury.

Definition. The diagnosis of drug induced NRH is usually based upon the following features. The diagnosis can certainly be considered probable without a liver biopsy if there are no other features of cirrhosis and a typically implicated drug is being used.

1 Latency of more than 6 months
2 Minimal or no elevations in serum ALT (<120 U/L: <3 times ULN) or alkaline phosphatase (<345 U/L: <3 times ULN)
3 Clinical, radiologic or endoscopic signs of portal hypertension (ascites, splenomegaly, abdominal venous collaterals, varices, portal hypertensive gastropathy)
4 Liver biopsy showing nodularity with minimal or no fibrosis.

## Representative Cases

### Case 1. Nodular regenerative hyperplasia during azathioprine therapy for inflammatory bowel disease.

[Modified from: Daniel F, Cadranel JF, Seksik P, Cazier A, Duong Van Huyen JP, Ziol M, Coutarel P, et al. Azathioprine induced nodular regenerative hyperplasia in IBD patients. Gastroenterol Clin Biol 2005; 29: 600-34. PubMed Citation]

A 44 year old man with severe ulcerative colitis requiring long term corticosteroid therapy was started on azathioprine (2.5 mg/kg/day) and was found to develop liver test abnormalities six months later. Serum aminotransferase levels, alkaline phosphatase and gamma glutamyl transpeptidase (GGT) were 1.1 to 1.7 times the upper limit of normal (ULN). Serum bilirubin and prothrombin time were normal and all tests for viral hepatitis and autoimmune markers were negative. The platelet count had fallen from normal to 129,000/μL. Hepatic imaging using magnetic resonance and ultrasound were normal. Endoscopy did not reveal esophageal varices or portal hypertensive gastropathy. A liver biopsy, however, showed early changes of nodular regenerative hyperplasia with scant inflammation and no evidence of injury to central veins or bile ducts. During the ensuing 6 to 9 months, serum GGT levels continued to rise, and eventually azathioprine was stopped. Subsequently, GGT levels fell gradually and the platelet count stabilized in the low-normal range. The patient remained asymptomatic of liver disease, and subsequently the ulcerative colitis was adequately controlled with corticosteroids only.

#### Key Points

Medication: | Azathioprine (200 mg/day for 16 months)
Pattern: | Cholestatic (R=0.9)
Severity: | 1+ (asymptomatic liver test abnormalities)
Latency: | 6 months
Recovery: | Unclear
Other medications: | Prednisolone

#### Laboratory Values

Time After Starting | Time After Stopping | GGT (times ULN) | Platelets (1000/uL) | Other
0 | Pre | 1.0 | 320
6 months | Pre | 1.1 | 129
12 months | 0 | 10.2 | 110
18 months | 6 months | 9.0 | 145
24 months | 12 months | 7.2 | 110
30 months | 18 months | 5.9 | 110
36 months | 24 months | 1.5 | 150
Normal Values | <40 | <31 | >165

#### Comment

Nodular regenerative hyperplasia can arise fairly rapidly during long term therapy with thiopurines such as azathioprine. The condition is largely asymptomatic, but clues to its presence include minimal liver test abnormalities (particularly GGT) and a fall in platelet count. Imaging usually demonstrates enlargement of the spleen and mild abnormalities in the appearance of the liver. With progression of nodular transformation, portal hypertension can arise and distinct hepatic decompensation can occur as a complication of incurrent infections, variceal hemorrhage or renal failure.

### Case 2. Nodular regenerative hyperplasia due to oxaliplatin.

[DILIN Case 109-0028]

A 69 year old woman with colorectal cancer developed fatigue and weakness after 20 weeks of oxaliplatin and 5 fluorouracil therapy, given as weekly intravenous infusions. She subsequently developed anorexia, leg swelling, dark urine and jaundice. She had no history of liver disease and did not drink alcohol or have risk factors for viral hepatitis. Her only other medication was folinic acid and she denied taking over the counter medications, herbals or nutritional supplements. On examination, she was jaundiced and had evidence of ascites and peripheral edema. Laboratory testing showed serum bilirubin 0f 2.1 mg/dL, ALT 80 U/L, AST 121 U/L and alkaline phosphatase 299 U/L, which were increased from previous values taken during clinical monitoring of the cancer chemotherapy (Table). Despite stopping chemotherapy, her liver tests continued to worsen, serum bilirubin rising to 3.6 mg/dL and INR to 1.47. Tests for acute hepatitis A, B and C were negative. Abdominal ultrasound showed a heterogeneous liver echotexture and magnetic resonance imaging showed gallstones, a heterogeneous liver and ascites, but no evidence of metastatic disease. A liver biopsy showed venous outflow obstruction. In follow up, her symptoms gradually resolved and liver tests fell into the normal or near-normal range but six months later, an abdominal MRI showed evidence of esophageal varices.

#### Key Points

Medication: | Oxaliplatin
Pattern: | Minimal serum enzyme elevations, presentation with ascites
Severity: | 4+ (jaundice and ascites)
Latency: | 5 months
Recovery: | 3 months, but residual portal hypertension
Other medications: | 5-fluorouracil, folinic acid

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | Start of once weekly infusions of oxaliplatin and 5-fluorouracil
4 weeks | | 33 | 168 | 0.3
8 weeks | | 36 | 98 | 0.5
12 weeks | | 31 | 164 | 0.6
16 weeks | | 35 | 233 | 1.2
20 weeks | 0 | 80 | 299 | 2.1 | Fatigue and anorexia
| 2 weeks | 89 | 294 | 3.2 | Dark urine and jaundice
| 3 weeks | 125 | 288 | 3.0 | Liver biopsy
6 months | 4 weeks | 155 | 268 | 3.5
| 5 weeks | 110 | 256 | 3.6
| 6 weeks | 106 | 232 | 3.4
| 8weeks | 60 | 224 | 2.2
| 12 weeks | 35 | 201 | 0.9
| 16 weeks | 34 | 157 | 0.8
| 20 weeks | 26 | 142 | 0.5 | MRI: Esophageal varices
1 year | 24 weeks | 21 | 132 | 0.8
| 30 weeks | 21 | 115 | 1.0
| 40 weeks | 24 | 124 | 0.9
Normal Values | | <31 | <120 | <1.2

#### Comment

Cyclic chemotherapy with oxaliplatin has been associated with development of venous flow obstruction and evidence of portal hypertension within 6 to 12 months of starting. The histology actually demonstrates nodular regenerative hyperplasia and the clinical presentation is dominated by signs and symptoms of portal hypertension. Serum enzymes are only modestly elevated and, by themselves, would be little matter of concern. The presence of jaundice, symptoms of fatigue and fluid overload with ascites and edema, however, indicates that the injury is potentially severe.

## Histologic Images

Photomicrographs by

David E. Kleiner, MD, PhD

Laboratory of Pathology

National Cancer Institute

(See high resolution images)

Oxaliplatin Injury

Histologic Features to Note:

There is sinusoidal dilation present (arrows). There is no inflammatory infiltrate and no areas of necrosis.

(See high resolution image)

Oxaliplatin Injury: There is sinusoidal dilation present (arrows). There is no inflammatory infiltrate and no areas of necrosis.

Oxaliplatin Injury

Histologic Features to Note:

In the areas showing sinusoidal dilation the sinuses are congested and the hepatocyte plates are narrowed. Note that in this preparation, the red blood cells are pale pink rather than bright red. The cells containing brown pigment are macrophages loaded with iron.

(See high resolution image)

Oxaliplatin Injury: In the areas showing sinusoidal dilation the sinuses are congested and the hepatocyte plates are narrowed. Note that in this preparation, the red blood cells are pale pink rather than bright red. The cells containing brown pigment are macrophages loaded with iron.

Oxaliplatin Injury

Histologic Features to Note:

The Masson trichrome stain shows delicate perisinusoidal fibrosis (blue stain), particularly in the areas of sinusoidal dilation. In the center of the photo there is a blue stained scar that probably represents a scarred and occluded vein (V)

(See high resolution image)

Oxaliplatin Injury: The Masson trichrome stain shows delicate perisinusoidal fibrosis (blue stain), particularly in the areas of sinusoidal dilation. In the center of the photo there is a blue stained scar that probably represents a scarred and occluded vein (V)

Oxaliplatin Injury

Histologic Features to Note:

A reticulin stain highlights the sinusoidal architecture of the liver. Normally the liver cell plates (lined by dark‐staining reticulin fibers), should be of equal width—1 hepatocyte wide. In this photo there is a nodule in the center of the field in which the plates in the center of the nodule are wide and the plates at the edge are narrowed (arrows). This change, in the absence of significant fibrosis, is indicative of nodular regenerative hyperplasia.

(See high resolution image)

Oxaliplatin Injury: A reticulin stain highlights the sinusoidal architecture of the liver. Normally the liver cell plates (lined by dark‐staining reticulin fibers), should be of equal width—one hepatocyte wide. In this photo there is a nodule in the center of the field in which the plates in the center of the nodule are wide and the plates at the edge are narrowed (arrows). This change, in the absence of significant fibrosis, is indicative of nodular regenerative hyperplasia.

Oxaliplatin Injury

Histologic Features to Note:

The liver cell plates in the center of the nodule are more than one hepatocyte wide.

(See high resolution image)

Oxaliplatin Injury: The liver cell plates in the center of the nodule are more than one hepatocyte wide.

Oxaliplatin Injury

Histologic Features to Note:

The liver cell plates at the edge of the nodule are one hepatocyte wide, but the hepatocytes are narrower than normal.

(See high resolution image)

Oxaliplatin Injury: The liver cell plates at the edge of the nodule are one hepatocyte wide, but the hepatocytes are narrower than normal.

## Selected References

1 Buffet C, Cantarovitch M, Pelletier G, Fabre M, Martin E, Charpentier B, Etienne JP, et al. (1988). Three cases of nodular regenerative hyperplasia of the liver following renal transplantation. Nephrol Dial Transplant. (Three men, ages 22, 29 and 50 years, developed nodular regenerative hyperplasia with hepato-splenomegaly 24-30 months after renal transplant and while receiving azathioprine; two had peliosis and one sinusoidal obstruction syndrome; minimal liver test abnormalities in two; jaundice in the third who had a fatal outcome [initial bilirubin 5.8 mg/dL, AST 35 U/L, Alk P 80 U/L]).
2 Snover DC, Weisdorf S, Bloomer J, McGlave P, Weisdorf D. (1989). Nodular regenerative hyperplasia of the liver following bone marrow transplantation. Hepatology. (Retrospective review of liver histology from 101 patients after bone marrow transplantation found veno-occlusive disease in 9% vs nodular regeneration in 23%, which were often clinically indistinguishable).
3 Vassal G, Hartmann O, Benhamou E. (1990). Busulfan and veno-occlusive disease of the liver. Ann Intern Med. (Among 403 children receiving busulfan for bone marrow transplantation, 28 [7%] developed veno-occlusive disease and 3 died; occurrence associated with higher doses).
4 Shepherd P, Harrison DJ. (1990). Idiopathic portal hypertension associated with cytotoxic drugs. J Clin Pathol. (4 cases of portal hypertension developing in patients on thioguanine and busulfan for leukemia or chlorambucil for Hodgkin's disease after 21-70 months, often with variable elevations in alkaline phosphatase).
5 Shepherd PC, Fooks J, Gray R, Allan NC. (1991). Thioguanine used in maintenance therapy of chronic myeloid leukaemia causes non-cirrhotic portal hypertension. Results from MRC CML. II. Trial comparing busulphan with busulphan and thioguanine. Br J Haematol. (Among 674 patients with chronic leukemia, 18 of 337 treated with busulphan and thioguanine developed portal hypertension after 1 to 8 years [median 2 years] compared to none of 338 given busulphan alone, whereas liver test abnormalities [~50%] and jaundice [~3%] occurred in similar proportions of both groups).
6 Daniel F, Cadranel JF, Seksik P, Cazier A, Duong Van Huyen JP, Ziol M, Coutarel P, et al. (2005). Azathioprine induced nodular regenerative hyperplasia in IBD patients. Gastroenterol Clin Biol. (Four men, ages 26 to 46 years, with inflammatory bowel disease developed nodular regenerative hyperplasia 6-12 months after starting azathioprine, presenting with liver test abnormalities and decrease in platelet counts, improving with stopping including slight increase in platelet count: Case 1).
7 Reshamwala PA, Kleiner DE, Heller T. (2006). Nodular regenerative hyperplasia: not all nodules are created equal. Hepatology. (Review of the definition, pathology, clinical features, diagnosis, natural history, treatment and etiology of nodular regenerative hyperplasia).
8 Mallet V, Blanchard P, Verkarre V, Vallet-Pichard A, Fontaine H, Lascoux-Combe C, Pol S. (2007). Nodular regenerative hyperplasia is a new cause of chronic liver disease in HIV-infected patients. AIDS. (Among 8 patients with HIV infection referred for evaluation of liver disease of unknown cause, all had nodular regenerative hyperplasia and had received didanosine [and many received stavudine or zidovudine] for 1 to 2 years [bilirubin 0.2-2.0 mg/dL, ALT 0.4-2.0 times ULN, Alk P 0.9-19.1 times ULN, platelets 71-149,000/.L], all had varices and 5 had ascites).
9 Slade JH, Alattar ML, Fogelman DR, Overman MJ, Agarwal A, Maru DM, Coulson RL, et al. (2009). Portal hypertension associated with oxaliplatin administration: clinical manifestations of hepatic sinusoidal injury. Clin Colorectal Cancer. (Six patients developed noncirrhotic portal hypertension after 6 to 12 cycles of oxaliplatin and 5-FU chemotherapy [6-15 months] for metastatic colorectal cancer, including 3 men, 3 women, ages 37 to 69 years, all of whom developed thrombocytopenia [53-128,000/µL], splenomegaly and varices, 2 wth variceal hemorrhage and 2 with ascites).
10 Dinh MH, Stosor V, Rao SM, Miller FH, Green RM. (2009). Cryptogenic liver disease in HIV-seropositive men. HIV Med. (Among 9 patients with HIV infection referred for evaluation of liver disease of unknown cause, 3 had nodular regenerative hyperplasia and several others had portal hypertension without cirrhosis; no mention of antiretroviral regimens).
11 Hartleb M, Gutkowski K, Milkiewicz P. (2011). Nodular regenerative hyperplasia: evolving concepts on underdiagnosed cause of portal hypertension. World J Gastroenterol. (Review of etiology, course and management of nodular regenerative hyperplasia; mentions its association with azathioprine, mercaptopurine, thioguanine, oxaliplatin and antiretroviral agents).